# Linezolid

## OVERVIEW

### Introduction

Linezolid is an oxazolidinone class antibiotic that is used for serious or problematic infections caused by resistant enterococcal or staphylococcal organisms. Prolonged therapy with linezolid has been linked to rare instances of lactic acidosis and liver injury probably as a result of hepatic mitochondrial toxicity.

### Background

Linezolid (lin ayz' oh lid) is a synthetic antibiotic that belongs to the oxazolidinone class. It has broad bacteriocidal activity against gram positive organisms such as enterococci and staphylococci and most streptococci. It also has moderate activity against Mycobacterium tuberculosis. Linezolid acts by blocking bacterial protein synthesis, probably as a result of blocking the formation of the functional ribosomal 70S subunit. Linezolid was approved for use in the United States in 2000 and is currently indicated for treatment of vancomycin-resistant enterococcal infections, for nosocomial pneumonia due to staphylococci (either methicillin-sensitive or -resistant) and skin and tissue infections caused by Staphylococcus aureus or pyogenes. Because of its activity against multidrug resistant enterococci and staphylococci, the use of linezolid is usually reserved for severe infections where methicillin or penicillin resistance is found. Linezolid is also used in some regimens for therapy of multidrug resistant tuberculosis. Linezolid is available in tablets of 400 and 600 mg generically and under the name Zyvox. It is also available as an oral suspension and a solution for intravenous administration. Linezolid is typically given as a 7 to 14 day course of 400 or 600 mg twice daily. Longer courses are sometimes used for persistent infections. Common minor side effects include nausea, diarrhea, abdominal upset, headache and skin rash. Rare, but severe side effects include serotonin syndrome, thrombocytopenia, optic and peripheral neuropathy, pancreatitis and lactic acidosis.

### Hepatotoxicity

Therapy with linezolid has been associated with mild and transient elevations in serum aminotransferase and alkaline phosphatase levels in 1% to 10% of patients, although similar rates of elevations occur in patients with infections treated with comparable agents, and enzyme elevations were not found in normal volunteers given linezolid for short periods. On the other hand, ALT elevations during therapy have been higher with higher doses of linezolid, but in all instances the elevations occurred without symptoms and resolved with discontinuation of the drug.

Although the agent has been available for a limited time and its use has been restricted, several instances of clinically apparent liver disease with jaundice have been reported with linezolid therapy. A case of a hypersensitivity response with rash, eosinophilia and renal insufficiency (DRESS syndrome) with mild serum enzyme elevations has been reported. More frequently, linezolid has been linked to cases of lactic acidosis, generally arising after 1 to 8 weeks of therapy and sometimes associated with evidence of liver injury and jaundice. Lactic acidosis is usually due to injury and dysfunction of hepatic mitochondria, with resulting microvesicular steatosis and disturbed hepatic function (not necessarily accompanied by jaundice or even ALT or alkaline phosphatase elevations). Other serious side effects associated with mitochondrial damage due to linezolid therapy include peripheral and optic neuropathy, pancreatitis, serotonin syndrome and renal injury. Risk factors for developing lactic acidosis from linezolid include higher doses, longer courses of therapy and underlying chronic liver or renal disease. The mitochondrial injury is believed to be due to the inhibition of mitochondrial ribosomal function that matches the known effect of linezolid on bacterial ribosomal function. Lactic acidosis occurs after 1 to 8 weeks of treatment and can be severe, although it often resolves rapidly with discontinuation. In contrast, the optic and peripheral neuropathy due to linezolid resolves more slowly and can be permanent. Lactic acidosis can be fatal and hepatic dysfunction and jaundice have been mentioned in severe cases of lactic acidosis attributed to linezolid.

Likelihood score: A (well established cause of clinically apparent liver injury usually in association with lactic acidosis).

### Mechanism of Injury

The etiology of serum enzyme elevations during linezolid therapy is not known and may relate more to the underlying condition rather than injury from linezolid. Lactic acidosis and peripheral neuropathy from linezolid are probably due to inhibition of mitochondrial ribosomal function and protein synthesis. Indeed, a mitochondrial 16S ribosomal RNA polymorphism [A2706G] has been identified in a high proportion of patients who developed lactic acidosis while on linezolid that may have represented a genetic predisposition to this adverse event. The polymorphism is in the linezolid binding site of the homologous region of bacterial 23S ribosomal RNA and thus the inhibition of mitochondrial ribosomal function may be an off-target but direct toxic effect of linezolid.

### Outcome and Management

The serum aminotransferase and alkaline phosphatase elevations that occur during linezolid therapy are self-limited and resolve once therapy is stopped. There are no reports of cross sensitization and hepatic injury from linezolid in persons with hepatic injury from other antibiotics or sulfonamides. The lactic acidosis due to linezolid has been linked to injury to hepatic mitochondria and with microvesicular steatosis, but is usually rapidly reversed with withdrawal of therapy. Treatment with carnitidine, antioxidants, thiamine and prednisone has been used, but has not been shown to be effective. Use of intravenous 20% glucose infusions, which are effective in treating the lactic acidosis of acute fatty liver of pregnancy, Reye syndrome and fialuridine therapy, has not been studied. In some instances hemodialysis has been used to rapidly decrease linezolid levels and help correct electrolyte and fluid imbalance.

Drug Class: Antiinfective Agents, Miscellaneous, Oxazolidinones

Other Drugs in the Subclass, Oxazolidinones: Tedizolid

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Linezolid – Zyvox®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=linezolid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Linezolid | 165800-03-3 | C16-H20-F-N3-O4 | Linezolid chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 6 June 2019

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. pp 589-637. (Expert review of hepatotoxicity published in 1999, before the availability of linezolid which is not mentioned).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibiotics; linezolid is not discussed).
MacDougall C, Chambers HF. Oxazolidinones (Linezolid). Protein synthesis inhibitors; miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
Stevens DL, Smith LG, Bruss JB, McConnell-Martin MA, Duvall SE, Todd WM, et al. Randomized comparison of linezolid (PNU-100766) versus oxacillin-dicloxacillin for treatment of complicated skin and soft tissue infections. Antimicrob Agents Chemother 2000; 44: 3408-13. (836 patients treated for average of 13 days at 133 centers, 2/3 cured, no serious adverse events attributed to linezolid and no "significant" changes in chemistry tests). 11083648
Antony SJ, Diaz-Vasquez E, Stratton C. Clinical experience with linezolid in the treatment of resistant gram-positive infections. J Natl Med Assoc 2001; 93: 386-91. (Among 19 patients with serious resistant Gram positive infections treated with linezolid on a compassionate use basis, 79% had clinical cure; two patients had mild elevations in liver tests, but no details given). 11688919
Kaplan SL, Patterson L, Edwards KM, Azimi PH, Bradley JS, Blumer JL, et al.; Linezolid Pediatric Pneumonia Study Group. Pharmacia and Upjohn. Linezolid for the treatment of community-acquired pneumonia in hospitalized children. Linezolid Pediatric Pneumonia Study Group. Pediatr Infect Dis J 2001; 20: 488-94. (Phase II trial of iv followed by oral linezolid in 78 children treated for 6 to 41 days; ALT elevations occurred in 6.4% [75-253 U/L], but all resolved in follow up). 11368105
Rubinstein E, Cammarata S, Oliphant T, Wunderink R; Linezolid Nosocomial Pneumonia Study Group. Linezolid (PNU-100766) versus vancomycin in the treatment of hospitalized patients with nosocomial pneumonia: a randomized, double-blind, multicenter study. Clin Infect Dis 2001; 32: 402-12. (396 patients treated with either linezolid or vancomycin at 90 sites had similar rates of clinical response and side effects; liver tests were abnormal in 1.0% of linezolid vs 1.6% of vancomycin treated patients). 11170948
Apodaca AA, Rakita RM. Linezolid-induced lactic acidosis. N Engl J Med 2003; 348: 86-7. (52 year old woman developed intractable nausea and vomiting 11 weeks after starting linezolid and was found to have lactic acidosis [9.9 μmol/L] which was reversed after stopping drug; no mention of hepatic abnormalities). 12510056
Bernard L, Stern R, Lew D, Hoffmeyer P. Serotonin syndrome after concomitant treatment with linezolid and citalopram. Clin Infect Dis 2003; 36: 1197. (81 year old man developed severe lactic acidosis, thrombocytopenia and serotonin syndrome 3 weeks after starting linezolid while also taking citalopram [ALT 66 U/L, CPK 766 U/L, lactate 17.5 μmol/L, pH 6.9], leading to cardiac arrest and hepatic failure, but no information on liver function or histology were given). 12715317
French G. Safety and tolerability of linezolid. J Antimicrob Chemother 2003; 51 (Suppl 2): ii45-53. (Review of adverse events reported in clinical trials of linezolid reported similar rates of adverse events to comparative drugs; diarrhea, nausea and headache in 1-5%: abnormal "liver tests" in 1.0% vs 0.3% of controls. In one study ALT elevations occurred in 2.5% with low- and 9.8% with high-dose linezolid, all elevations were mild and reversible, and similar in rate to comparative agents; overall ALT >2 times ULN occurred in 7.4% vs 7.2%; list of serious adverse events includes "hepatitis"). 12730142
Moellering RC. Linezolid: the first oxazolidinone antimicrobial. Ann Intern Med 2003; 138: 135-42. (Clinical review of linezolid use; no mention of hepatic injury). 12529096
Rubinstein E, Isturiz R, Standiford HC, Smith LG, Oliphant TH, Cammarata S, et al. Worldwide assessment of linezolid's clinical safety and tolerability: comparator-controlled phase III studies. Antimicrob Agents Chemother 2003; 47: 1824-31. (Safety assessment in 2046 patients who received linezolid vs 2001 on comparator drugs found similar rates of diarrhea [4.3 vs 3.2%], nausea [3.4 vs 2.3%], headache [2.2 vs 1.3%], liver test abnormalities [1.0 vs 0.3%], serious adverse events [11.4 vs 10.6%], and deaths [4.8 vs 4.9%]; two patients on oxacillin-dicloxacillin developed "hepatitis", but no cases described for linezolid cohort). 12760854
Stalker DJ, Jungbluth GL, Hopkins NK, Batts DH. Pharmacokinetics and tolerance of single- and multiple-dose oral or intravenous linezolid, an oxazolidinone antibiotic, in healthy volunteers. J Antimicrob Chemother 2003; 51: 1239-46. (Healthy volunteers given linezolid for up to 18 days had no "clinically important" changes from baseline in laboratory values). 12668582
Palenzuela L, Hahn NM, Nelson RP Jr, Arno JN, Schobert C, Bethel R, Ostrowski LA, et al. Does linezolid cause lactic acidosis by inhibiting mitochondrial protein synthesis? Clin Infect Dis 2005; 40: e113-6. (Three women, ages 49 to 74, developed lactic acidosis 7-12 weeks after starting linezolid [lactate 9.9 to 18.4 mmol/L] and 2 of the 3 were found to have an polymorphism in mitochondrial 16S rRNA [A2706G] at a site that was homologous to the bacterial 23S rRNA binding site of linezolid). 15909253
Kopterides P, Papadomichelakis E, Armaganidis A. Linezolid use associated with lactic acidosis. Scand J Infect Dis 2005; 37: 153-4. (Elderly man with severe methicillin-resistant staphylococcus aureus infection developed rising lactate (2.0→12.5 μmol/L) over 7 days of linezolid therapy, resolved with discontinuation, no evidence of liver injury). 15764207
Soriano A, Miró O, Mensa J. Mitochondrial toxicity associated with linezolid. N Engl J Med 2005; 353: 2305-6. (Three patients with asthenia and lactic acidosis after 1.5-3 months of linezolid therapy were studied for mitochondrial function in peripheral blood mononuclear cells; complex IV enzymatic activity was decreased). 16306535
Bishop E, Melvani S, Howden BP, Charles PG, Grayson ML. Good clinical outcomes but high rates of adverse reactions during linezolid therapy for serious infections: a proposed protocol for monitoring therapy in complex patients. Antimicrob Agents Chemother 2006; 50: 1599-602. (Retrospective analysis of 44 patients treated with linezolid for more than 7 days (8-185 days) found cure in 73%, but adverse reactions in 64%, including 25% requiring ICU care: platelet decreases, anemia, gastrointestinal upset, and 10% with serious adverse events of neuropathy, serotonin syndrome and/or lactic acidosis; recommended prospective monitoring). 16569895
De Vriese AS, Coster RV, Smet J, Seneca S, Lovering A, Van Haute LL, et al. Linezolid-induced inhibition of mitochondrial protein synthesis. Clin Infect Dis 2006; 42: 1111-7. (Patient treated with linezolid and rifampicin for 4 months developed loss of vision and lactic acidosis [24.5 μmol/L], renal failure and flaccid paralysis; muscle, liver, kidney and white cells were studied; liver showed micro- and macro-vesicular steatosis, decreased activity and protein of respiratory chain complexes I and IV in mitochondria, but normal mtDNA and morphology by electron microscopy). 16575728
Jaksic B, Martinelli G, Perez-Oteyza J, Hartman CS, Leonard LB, Tack KJ. Efficacy and safety of linezolid compared with vancomycin in a randomized, double-blind study of febrile neutropenic patients with cancer. Clin Infect Dis 2006; 42: 597-607. (Controlled trial of linezolid vs vancomycin for an average of 11 days in 453 patients with cancer and febrile neutropenia found similar safety and efficacy; "the distribution of biochemical test results, including mean values, changes from baseline values and abnormal values, was similar between groups"). 16447103
McKee EE, Ferguson M, Bentley AT, Marks TA. Inhibition of mammalian mitochondrial protein synthesis by oxazolidinones. Antimicrob Agents Chemother 2006; 50: 2042-9. (Like chloramphenicol and tetracycline, the oxazolidinones bind to bacterial as well as mitochondrial ribosomes and inhibit protein synthesis, the binding site being conserved between mitochondrial and gram-positive bacteria). 16723564
Pea F, Scudeller L, Lugano M, Baccarani U, Pavan F, Tavio M, et al. Hyperlactacidemia potentially due to linezolid overexposure in a liver transplant recipient. Clin Infect Dis 2006; 42: 434-5. (59 year old liver transplant recipient developed increased lactate levels after 11 days of linezolid therapy, returning to normal with discontinuation; no mention of other liver tests). 16392096
Narita M, Tsuji BT, Yu VL. Linezolid-associated peripheral and optic neuropathy, lactic acidosis, and serotonin syndrome. Pharmacotherapy 2007; 27: 1189-97. (Review and summary of published literature on severe side effects of linezolid). 17655517
Vardakas KZ, Ntziora F, Falagas ME. Linezolid: effectiveness and safety for approved and off-label indications. Expert Opin Pharmacother 2007; 8: 2381-400. (Review of pharmacokinetics, efficacy and safety of linezolid with no mention of hepatic abnormalities). 17927491
Wiener M, Guo Y, Patel G, Fries BC. Lactic acidosis after treatment with linezolid. Infection. 2007; 35: 278-81. (80 year old woman presented with shortness of breath and lactic acidosis after 19 days of linezolid [pH 7.0, lactate 19 μmol/L], with rapid recovery upon switching to daptomycin). 17646908
Carson J, Cerda J, Chae JH, Hirano M, Maggiore P. Severe lactic acidosis associated with linezolid use in a patient with the mitochondrial DNA A2706G polymorphism. Pharmacotherapy 2007; 27: 771-4. (35 year old woman with HIV/AIDS developed pancreatitis and lactic acidosis 35 days after starting linezolid [lactate 205 mg/dL, pH 7.16], and sequencing of mitochondrial rRNA showed the A2706G polymorphism described by Palenzuela [2005]). 17461714
Metzxas EI, Falagas ME. Update on the safety of linezolid. Expt Opin Drug Saf 2009; 8: 485-91. (Summary of pooled results of clinical trials of linezolid in 2046 patients; severe side effects occurred in 0.4% including cytopenia, neurological side effects and lactic acidosis; ALT elevations also occurred, and "some patients had to discontinue treatment because of these abnormalities"). 19538105
Savard S, Desmeules S, Riopel J, Agharazii M. Linezolid-associated acute interstitial nephritis and drug rash with eosinophilia and systemic symptoms (DRESS) syndrome. Am J Kidney Dis 2009; 54: e17-20. (84 year old woman developed pruritus, rash, facial edema and eosinophilia on the 7th day of linezolid therapy with interstitial nephritis and mild hepatitis [AST ~90 U/L, GGT ~105 U/L], with rapid response to prednisone after stopping linezolid). 19733945
De Bus L, Depuydt P, Libbrecht L, Vandekerckhove L, Nollet J, Benoit D, Vogelaers D, Van Vlierberghe H. Severe drug-induced liver injury associated with prolonged use of linezolid. J Med Toxicol 2010; 6: 322-6. (55 year old woman developed jaundice and lactic acidosis after 50 days of linezolid and meropenem therapy [bilirubin 12.1 mg/dL, ALT 113 U/L, Alk P 2486 U/L, pH 7.27, lactate 121 mg/dL], with signs of liver failure, but resolving spontaneously over next 3 months). 20358416
Garazzino S, Tovo PA. Clinical experience with linezolid in infants and children. J Antimicrob Chemother 2011; 66 Suppl 4: iv23-iv41. (Linezolid has been approved for use in children in whom side effects appear to be less common; transient elevations in serum aminotransferase levels may occur during therapy). 21521704
Gould FK. Linezolid: safety and efficacy in special populations. J Antimicrob Chemother 2011; 66 Suppl 4: iv3-iv6. (Review that states "Linezolid can induce hepatic transaminases and has been associated with cholestasis, but these abnormalities are infrequent, minor and rarely lead to therapy being truncated"). 21521705
Carson J, Cerda J, Chae JH, Hirano M, Maggiore P. Severe lactic acidosis associated with linezolid use in a patient with the mitochondrial DNA A2706G polymorphism. Pharmacotherapy 2007; 27: 771-4. (35 year old woman developed severe lactic acidosis 35 days after starting linezolid; had mitochondrial DNA polymorphism that may have predisposed her to injury). 17461714
Scotton P, Fuser R, Torresan S, Carniato A, Giobbia M, Rossi C, Inojosa WO, Vaglia A. Early linezolid-associated lactic acidosis in a patient treated for tuberculous spondylodiscitis. Infection 2008; 36: 387-8. (81 year old woman developed acidosis 12 days after starting intravenous linezolid [pH 7.24, lactate 18.6 mmol/L], isoniazid, rifampin and ethambutol for atypical tuberculosis, recovering within a week of stopping and later tolerating isoniazid, pyrazinamide and rifampin). 18642110
Lee YR, Powell N, Bonatti H, Sawyer RG, Barroso L, Pruett TL, Sifri CD, Volles D. Early development of lactic acidosis with short term linezolid treatment in a renal recipient. J Chemother 2008; 20: 766-7. (56 year old woman with urosepsis and renal transplant developed metabolic acidosis which worsened with linezolid therapy, but resolved once it was stopped). 19129081
Boutoille D, Grossi O, Depatureaux A, Tattevin P. Fatal lactic acidosis after prolonged linezolid exposure for treatment of multidrug-resistant tuberculosis. Eur J Intern Med 2009; 20: e134-5. (48 year old man developed lactic acidosis 3 months after starting oral linezolid for resistant tuberculosis [pH 7.32, lactate 11.6 mmol/L], while linezolid was stopped, he was found dead 3 weeks later). 19782904
Fernández de Orueta L, Díaz V, Ramírez M, Alvarez R. [Linezolid-induced lactic acidosis]. Enferm Infecc Microbiol Clin 2009; 27: 550-1. (72 year old woman developed lactic acidosis beginning 34 days after starting linezolid with severe distress by day 39 [pH 6.93, lactate 6.1 mmol/L], resolving rapidly upon stopping). 19819595
Velez JC, Janech MG. A case of lactic acidosis induced by linezolid. Nat Rev Nephrol 2010; 6: 236-42. (36 year old man wtih end stage renal disease on dialysis developed lactic acidosis 6 weeks after starting oral linezolid for vancomycin resistant Enterococcus fecalis [pH 7.31, lactate 12.5 mmol/L, ALT 89 U/L], resolving within a week of stopping; ribsomal DNA polymorphism 2706A>G found, similar to two cases in the literature). 20348931
De Bus L, Depuydt P, Libbrecht L, Vandekerckhove L, Nollet J, Benoit D, Vogelaers D, et al. Severe drug-induced liver injury associated with prolonged use of linezolid. J Med Toxicol 2010; 6: 322-6. (55 year old woman developed jaundice and itching 6-7 weeks after starting linezolid and merepenem [bilirubin 12.1 mg/dL, ALT 113 U/L, Alk P 2,486 U/L, pH 7.27, lactate 121 mg/dL], with biopsy showing microvesicular steatosis and slowly resolving after stopping antibiotics, the patient later dying of septic shock). 20358416
Cope TE, McFarland R, Schaefer A. Rapid-onset, linezolid-induced lactic acidosis in MELAS. Mitochondrion 2011; 11: 992-3. (21 year old man with mitochrondrial encephalomyopathy, lactic acidosis and stroke-like episode syndrome [MELAS] developed tachypnea and rising lactate levels within a day of starting linezolid, returning to baseline rapidly upon stopping). 21907311
Su E, Crowley K, Carcillo JA, Michaels MG. Linezolid and lactic acidosis: a role for lactate monitoring with long-term linezolid use in children. Pediatr Infect Dis J 2011; 30: 804-6. (Three children [0.5, 0.5 and 16 years old], two boys and one girl, with hepatic and or intestinal insufficiency developed lactic acidosis during extended therapy [53, 31 and 7 days] with oral linezolid, resolving rapidly upon stopping in two, but with progressive acidosis and death in 1 child). 21852764
Contou D, Fichet J, Grimaldi D, Cariou A. Early life-threatening lactic acidosis following a single infusion of linezolid. Int J Antimicrob Agents 2011; 38: 84-5. (81 year old man with chronic hepatitis C on ventilatory support for pneumonia with Enterococcus fecalis superinfection developed lactic acidosis within hours of starting intravenous linezolid [pH 7.03, lactate 16 mmol/L], and resolving within hours of stopping). 21482079
Leach KL, Brickner SJ, Noe MC, Miller PF. Linezolid, the first oxazolidinone antibacterial agent. Ann N Y Acad Sci 2011 Mar; 1222: 49-54. (Overview from the sponsor of the discovery, development, mechanism of action, pharmacology, and spectrum of activity of linezolid, the first of a new class of antibiotics). 21434942
Garazzino S, Krzysztofiak A, Esposito S, Castagnola E, Plebani A, Galli L, Cellini M, et al. Use of linezolid in infants and children: a retrospective multicentre study of the Italian Society for Paediatric Infectious Diseases. J Antimicrob Chemother 2011; 66: 2393-7. (Retrospective analysis of 75 hospitalized children who received linezolid for an average of 26 days found that only 2 developed abnormal liver tests [>5 times ULN], but no details provided). 21764828
Simon A, Müllenborn E, Prelog M, Schenk W, Holzapfel J, Ebinger F, Klabunde-Cherwon A, et al. Use of linezolid in neonatal and pediatric inpatient facilities--results of a retrospective multicenter survey. Eur J Clin Microbiol Infect Dis 2012; 31: 1435-42. (Retrospective analysis of 108 children treated with linezolid [126 courses] in 9 hospitals in Germany and Austria found transiently elevated liver enzymes occurred during 5 courses, but no mention of clinically apparent liver injury). 22048844
Rose PC, Hallbauer UM, Seddon JA, Hesseling AC, Schaaf HS. Linezolid-containing regimens for the treatment of drug-resistant tuberculosis in South African children. Int J Tuberc Lung Dis 2012; 16: 1588-93. (Among 7 children with multidrug resistant tuberculosis treated with oral linezolid, 3 [all of whom were HIV infected and on antiretroviral therapy] had serious adverse events including 1 with pancreatitis [8 months], 1 with pancreatitis and lactic acidosis [7 months], and 1 with peripheral neuropathy and pancytopenia], 1 with lactic acidosis and 1 with bone marrow hypoplasia, resolving on stopping or lowering the dose of linezolid). 23032215
Miyawaki A, Ueda T, Nakao A, Adachi M, Ohya M, Yamada I, Takesue Y, et al. Linezolid-induced lactic acidosis followed by severe hypophosphatemia after discontinuation of linezolid. Surg Infect (Larchmt) 2013; 14: 229-30. (75 year old man developed lactic acidosis 72 days after starting oral linezolid [pH 7.09, lactate >25 mmol/L], developing severe hypophosphatemia, but ultimately recoverying completely; no mention of liver injury). 23464676
Kraleti S, Soultanova I. Pancytopenia and lactic acidosis associated with linezolid use in a patient with empyema. J Ark Med Soc 2013; 110: 62-3. (32 year old man developed pancytopenia, acidosis and enzyme elevations after a 14 day course of linezolid [bilirubin 1.5 mg/dL, ALT 29 U/L, Alk P 192 U/L, lactate 3.7 mmol/L], resolving within 10 days of stopping). 24079055
Holmaas G, Lærum JH, Schjøtt J, Leiva RA. A man in his seventies with a long-term infection and severe acid-base imbalance. Tidsskr Nor Laegeforen 2014; 134: 315-9. (70 year old man developed lactic acidosis while on long term linezolid [bilirubin not given, ALT 1080 U/L, Alk P normal, INR >7.5, pH 7.03, lactate 27 mmol/L], with prompt improvement on stopping drug). 24518482
Ozkaya-Parlakay A, Kara A, Celik M, Ozsurekci Y, Karadag Oncel E, Ceyhan M, Cengiz AB. Early lactic acidosis associated with linezolid therapy in paediatric patients. Int J Antimicrob Agents 2014; 44: 334-6. (Among 50 children treated with linezolid for severe infections for 3-93 days, 8 developed lactic acidosis [within 1-13 days] and 8 developed elevated lactate levels, but the elevations resolved despite continuation of therapy). 25182713
Sawyer AJ, Haley HL, Baty SR, McGuffey GE, Eiland EH 3rd. Linezolid-induced lactic acidosis corrected with sustained low-efficiency dialysis: a case report. Am J Kidney Dis 2014; 64: 457-9. (63 year old man with nocardiosis developed weakness on intravenous linezolid and doxyclycline and was found to have lactic acidosis [pH 7.04, lactate >180 mg/dL], which responded to stopping linezolid and dialysis; no liver tests results provided). 24961626
Del Pozo JL, Fernández-Ros N, Sáez E, Herrero JI, Yuste JR, Banales JM. Linezolid-induced lactic acidosis in two liver transplant patients with the mitochondrial DNA A2706G polymorphism. Antimicrob Agents Chemother 2014; 58: 4227-9. (Two liver transplant recipients [72 year old woman with nocardiosis and 43 year old man with tuberculosis] developed lactic acidosis 13 and 8 weeks after starting linezolid [pH 7.25 and 7.29, lactate 3.2 and 7.2 mmol/L, liver test results not provided], both responding to fluid resuscitation after stopping linezolid and both had the A2707G polymorphism in mitochondrial 16S rRNA). 24798272
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 were attributed to antibiotics, but none to linezolid or other oxazolidinone). 25754159
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94. (Among 824 patients receiving outpatient parenteral antibiotic therapy, 210 [25%] developed eosinophilia during treatment [median onset 15 days] inlcuding 10 of 31 recipients of linezolid, none of whom had DRESS syndrome or a serious cutaneous adverse reaction). 25981739
Djibré M, Pham T, Denis M, Pras Landre V, Fartoukh M. Fatal lactic acidosis associated with linezolid therapy. Infection 2015; 43: 125-6. (70 year old man with cirrhosis and recurrent sepsis developed lactic acidosis and shock 15 days after starting intravenous linezolid [bilirubin 6.7 mg/dL, ALT 20 U/L, AST 117 U/L, Alk P 118 U/L, pH 6.89, lactate 23 mmol/L] and died of multiorgan failure within days of presentation). 25326668
Johnson PC, Vaduganathan M, Phillips KM, O'Donnell WJ. A triad of linezolid toxicity: hypoglycemia, lactic acidosis, and acute pancreatitis. Proc (Bayl Univ Med Cent) 2015; 28: 466-8. (34 year old man with sickle cell disease developed pancreatitis and lactic acidosis 11 days after starting linezolid [lactate 23.5 mmol/L, pH 7.07, glucose 19 mg/dL, liver tests not provided], resolving rapidly upon stopping and administration of glucose; review of history demonstrated a previous episode of lactic acidosis after linezolid was given for 12 days, but not on 3 occasions when it was given for 1-6 days only). 26424943
Hsu SN, Shih MF, Yang CW, Wu CC, Chen CC. Severe linezolid-induced lactic acidosis in a cirrhosis patient. Nephrology (Carlton) 2015; 20: 47-8. (38 year old woman with alcoholic cirrhosis and renal disease developed lactic acidosis 12 days after starting linezolid [bilirubin 12.4 mg/dL, ALT 23 U/L, AST 64 U/L, INR 3.0, lactate 24 mmol/L, pH 6.9], treated successfully with hemodialysis). 25535870
Im JH, Baek JH, Kwon HY, Lee JS. Incidence and risk factors of linezolid-induced lactic acidosis. Int J Infect Dis 2015; 31: 47-52. (Among 144 patients with infections treated with either linezolid or telicoplatin in a retrospective, case-control analysis, definite or probable lactic acidosis arose in 5 receiving linezolid [vs none on telicoplatin] after 1-7 weeks, of whom 2 died; no mention of liver test abnormalities). 25499040
Santini A, Ronchi D, Garbellini M, Piga D, Protti A. Linezolid-induced lactic acidosis: the thin line between bacterial and mitochondrial ribosomes. Expert Opin Drug Saf 2017; 16: 833-43. (Review of the epidemiology, pathophysiology and risk factors for linezolid induced lactic acidosis; mentions 90 cases reported to the FDA, 243 to the European Registry and 48 published cases in adults [9 deaths] and 9 in children [3 deaths]). 28538105
Xiao B, Deng P, Jin H, Wang H, Cao Y. Lactic acidosis and thrombocytopenia associated with linezolid therapy: a case report. Am J Case Rep 2018; 19: 1117-20. (50 year old woman with endocarditis developed lactic acidosis 25 days after starting linezolid [bilirubin 8.3 mg/dL, lactate 19 mmol/L, pH 6.94], dying within weeks of multiorgan failure). 30232318
Mao Y, Dai D, Jin H, Wang Y. The risk factors of linezolid-induced lactic acidosis: A case report and review. Medicine (Baltimore) 2018; 97: e12114. (57 year old man with polymicrobial pneumonia and respiratory failure developed lactic acidosis after 3 doses of linezolid [lactate 10 mmol/L] responding partially to dialysis but ultimately dying from multiorgan failure; literature review identified 47 cases of linezolid associated lactic acidosis with a mortality rate of 26%). 30200095
Tobias PE, Varughese CA, Hanson AP, Gurnani PK. A case of linezolid induced toxicity. J Pharm Pract 2018 Jan 1: 897190018782787. [Epub ahead of print] (52 year old woman developed abdominal pain and confusion 6 weeks after starting linezolid and a carbapenem for a peritoneal abscess [bilirubin 1.1 mg/dL, ALT 82 U/L, Alk P 228 U/L, glucose 40 mg/dL, lactate 12.2 mmol/L, pH 7.33], resolving upon stopping linezolid, fluid resuscitation and hemodialysis). 29911459
Belani K, Leibowitz A, Bose S. Linezolid-induced lactic acidosis sets stage for surgery to rule out mesenteric ischemia: a case report. A A Pract 2018; 11: 93-5. (81 year old woman developed lactic acidosis within 12 days of starting linezolid [bilirubin not given, ALT 11 U/L, Alk P 133 U/L, pH 6.89, lactate 14.2 mmol/L] which was initially attributed to intestinal ischemia leading to laparotomy, but then resolved spontaneously within a day of stopping linezolid). 29634533
Cheng CN, Lin SW, Wu CC. Early linezolid-associated lactic acidosis in a patient with Child's class C liver cirrhosis and end stage renal disease. J Infect Chemother 2018; 24: 841-4. (63 year old man with Child's C cirrhosis developed lactic acidosis 2 weeks after starting linezolid, which resolved rapidly with stopping and did not recur on restarting at a lower dose). 29503228
Mori N, Kamimura Y, Kimura Y, Hirose S, Aoki Y, Bito S. Comparative analysis of lactic acidosis induced by linezolid and vancomycin therapy using cohort and case-control studies of incidence and associated risk factors. Eur J Clin Pharmacol 2018; 74: 405-11. (Retrospective analyses identified lactic acidosis arising in 10 of 94 patients [11%] receiving linezolid vs 1 of 313 [0.3%] receiving vancomycin; risk factors were duration of therapy and chronic renal disease). 29222713

## OTHER REFERENCE LINKS

1. Recent References on Linezolid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=linezolid+AND+Oxazolidinones/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Linezolid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=linezolid)